# Erlotinib

## OVERVIEW

### Introduction

Erlotinib is a tyrosine kinase receptor inhibitor that is used in the therapy of advanced or metastatic pancreatic or non-small cell lung cancer. Erlotinib therapy is associated with transient elevations in serum aminotransferase levels during therapy and rare instances of clinically apparent acute liver injury.

### Background

Erlotinib (er loe' ti nib) is a selective inhibitor of several tyrosine kinase receptors which are associated with tumor growth and angiogenesis. The tyrosine kinase receptors are often mutated and over expressed in tumor tissue and cause unregulated cell growth and proliferation. Erlotinib is one of several tyrosine kinase inhibitors that have been introduced into cancer chemotherapy and are specially directed at molecular abnormalities that occur in cancer cells. Inhibition of the receptor can lead to reversal of progression of the cancer, although clinical responses are sometimes limited by the development of tumor resistance caused by further mutations in the receptor gene. Erlotinib has special activity against the human epidermal growth factor (EGF) tyrosine kinase receptors HER-1 and EGFR which are found in several forms of cancer. Erlotinib received approval for use in the United States in 2004. Current indications are for locally advanced, unresectable or metastatic pancreatic cancer in combination with gemcitabine and for locally advanced or metastatic non-small-cell lung cancer as a first line treatment in patients with specific, erlotinib sensitive mutations in EGFR or after failure of at least one chemotherapy regimen. Erlotinib is available in tablets of 25, 100 and 150 mg under the brand name Tarceva, and the typical dose is either 100 mg (pancreatic cancer) or 150 mg (lung cancer) once daily by mouth, continued until disease progresses or intolerable toxicity occurs. Side effects include fatigue, rash, diarrhea, anorexia, skin discoloration, hand-foot syndrome, edema, muscle cramps, arthralgias, headache, abdominal discomfort, anemia, cough, and pruritus. Uncommon, but potentially severe side effects include heart failure, interstitial lung disease, gastrointestinal perforation, pancreatitis, renal failure, severe skin reactions and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during erlotinib therapy of pancreatic and lung cancers, and values above 5 times the upper limit of normal occur in at least 10% of patients. Similar rates of ALT elevations, however, can occur with comparable antineoplastic regimens. The abnormalities are usually asymptomatic and self-limited, but may require dose adjustment or discontinuation (Case 1). In addition, there have been rare reports of clinically apparent liver injury attributed to erlotinib therapy. The time to onset is typically within days or weeks of starting therapy, and the liver injury can be severe, there being at least a dozen fatal instances reported in the literature. The onset of injury can be abrupt and the pattern of serum enzyme elevations is usually hepatocellular (Case 2). Immunoallergic features (rash, fever and eosinophilia) are not common and autoantibody formation has not been reported. Routine monitoring of liver tests during therapy is recommended. The rate of clinically significant liver injury and hepatic failure is increased in patients with preexisting cirrhosis or hepatic impairment due to liver tumor burden.

Likelihood score: B (likely but uncommon cause of clinically apparent liver injury).

### Mechanism of Injury

The abrupt and severe nature of the clinically apparent liver injury attributed to erlotinib suggests that it is immunologically mediated. In contrast, the transient serum enzyme elevations that occur during therapy may have a different cause and be the result of direct toxicity. Erlotinib is metabolized in the liver through the cytochrome P450 system (largely CYP 3A4).

### Outcome and Management

Liver injury due to erlotinib varies in severity from minor, transient serum enzyme elevations to acute symptomatic hepatitis and acute liver failure. Monitoring of routine liver tests before starting and at regular intervals during erlotinib therapy is recommended. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within 3 weeks. Restarting therapy is usually, but not always followed by recurrence of the serum enzyme elevations. There appears to be partial cross sensitivity to liver injury among similar tyrosine kinase receptor inhibitors and, in some situations, switching to another with careful monitoring may be appropriate. Cases of acute liver failure have occurred in patients receiving erlotinib and are challenging as these patients rarely qualify for liver transplantation. Patients with acute liver failure due to erlotinib have been treated with corticosteroids, but there benefit remains unproven. In using this medication, other potentially hepatotoxic agents should be avoided (such as high doses of acetaminophen).

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## CASE REPORTS

### Case 1. Serum enzyme elevations due to erlotinib therapy.

[Modified from: Saif MW. Erlotinib-induced acute hepatitis in a patient with pancreatic cancer. Clin Adv Hematol Oncol 2008; 6: 191-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/18391918)]

A 52 year old man with locally advanced pancreatic cancer developed rising serum enzyme elevations 7 weeks after starting erlotinib therapy. He had presented initially with jaundice and was found to have a mass in the head of the pancreas that was shown to be adenocarcinoma by thin needle aspiration. He was treated initially with biliary stenting followed by gemcitabine, oxaliplatin and external beam radiation. Because of unresectability and oxaliplatin induced neuropathy, he was then treated with gemcitabine and erlotinib. His baseline liver tests were mildly abnormal and he was monitored carefully during erlotinib therapy. Seven weeks after stating erlotinib, serum ALT and alkaline phosphatase levels began to rise (Table). He was maintained on erlotinib and gemcitabine and monitored more carefully. Eleven weeks into treatment, however, serum enzymes had risen to more than 5 times the upper limit of the normal range. Tests for hepatitis A, B and C were negative and he was taking no other medications. Abdominal imaging showed no interval change in the pancreatic mass and no evidence of extrahepatic obstruction. Erlotinib was stopped and he was maintained on gemcitabine alone. Liver enzymes decreased to baseline values within the following 8 weeks.

#### Key Points

Medication: | Erlotinib (100 mg daily)
Pattern: | Cholestatic (R=1.9)
Severity: | 1+ (serum enzyme elevations only)
Latency: | 7-13 weeks
Recovery: | 8 weeks
Other medications: | Gemcitabine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
- 6 months | | 39 | 85 | 0.5
0 | | 53 | 176 | 0.5 | Erlotinib started
4 weeks | | 41 | 144 | 0.3
6 weeks | | 76 | 145 | 0.5
9 weeks | | 70 | 162 | 0.4 | CT scan: no change
11 weeks | | 131 | 283 | 0.3
13 weeks | 0 | 193 | 376 | 0.7 | Erlotinib stopped
14 weeks | 1 weeks | 199 | 346 | 0.3
15 weeks | 2 weeks | 288 | 491 | 0.4
16 weeks | 3 weeks | 157 | 444 | 0.2
19 weeks | 6 weeks | 85 | 259 | 0.3
22 weeks | 9 weeks | 62 | 176 | 0.4
Normal Values | | <35 | <130 | <1.2

#### Comment

The patient developed gradual increases in serum aminotransferase and alkaline phosphatase levels while being treated with erlotinib, and therapy was discontinued when ALT levels reached 5 times the upper limit of the normal range (considered Grade 3 toxicity). The severity of the liver injury, however, should be considered mild, as there was no jaundice and apparently no symptoms of hepatic injury. Because the patient had pancreatic cancer, the abnormalities could have indicated progressive malignant disease, particularly because of the cholestatic pattern of the enzymes and their gradual rise. However, imaging showed no evidence of an increase in the size of the pancreatic mass or evidence of biliary obstruction, and the abnormalities resolved once erlotinib was stopped. Grade 3 elevations in serum ALT levels occur in 5% to 10% of patients treated with erlotinib and gemcitabine, and this rate is only slightly higher than occurs with gemcitabine alone.

### Case 2. Acute liver failure and death due to erlotinib therapy.

[Modified from: Liu W, Makrauer FL, Qamar AA, Jänne PA, Odze RD. Fulminant hepatic failure secondary to erlotinib. Clin Gastroenterol Hepatol 2007; 5: 917-20. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/17625975)]

A 57 year old woman with metastatic non-small cell lung cancer and mutation of the EGFR gene in tumor tissue was treated with erlotinib (150 mg daily) and developed an acne-form skin rash 2 weeks later. The rash worsened and laboratory tests showed mild elevations in serum enzymes (ALT 80 U/L with normal AST and serum bilirubin). Because of the rash and stomatitis, erlotinib was stopped. The rash and mouth ulcers resolved rapidly and 2 weeks later erlotinib was restarted; however, 10 days later she developed anorexia and jaundice. She denied fever, chills, rash or abdominal pain. She had no history of liver disease, was not taking other medications, had no risk factors for viral hepatitis and was known to have had normal liver tests in the past (Table). On examination, she was jaundiced and appeared chronically ill. Laboratory tests showed a serum bilirubin of 13.6 mg/dL with marked elevations in serum ALT [2021 U/L] and AST [1476 U/L] and minor elevations in alkaline phosphatase [304 U/L]. Erlotinib was discontinued and she was admitted for management. Liver ultrasound and computerized tomography showed a small amount of ascites, but no evidence of hepatic masses or extrahepatic obstruction. A liver biopsy showed submassive hepatic necrosis with marked portal inflammation and ductular proliferation. Tests for hepatitis A, B and C and Epstein Barr virus infection were negative as were routine autoantibodies. Over the next few days, she experienced worsening jaundice, further prolongation of prothrombin time, hepatic encephalopathy and hepatorenal syndrome, and died on the 11th hospital day. Autopsy was refused.

#### Key Points

Medication: | Erlotinib (100 mg daily)
Pattern: | Hepatocellular (R=15)
Severity: | 5+ (acute liver failure and death)
Latency: | 11 days after restarting
Recovery: | None
Other medications: | Budesonide nasal spray and flunisolide inhaler

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
- 3 months | Pre | 19 | 89 | 0.6
0 | 0 | 30 | 99 | 0.5 | Erlotinib started
2 weeks | 0 | 82 | 119 | 0.6 | Skin rash
4 weeks | 0 | 57 | 69 | 1.9 | Erlotinib stopped
Erlotinib restarted 2 weeks after discontinuation, and 1 week after resolution of rash
11 days | 0 | 2021 | 304 | 13.6 | INR=2.0, Erlotinib stopped
14 days | 2 days | 2037 | 174 | 18.1 | Liver biopsy
17 days | 5 days | 857 | 137 | 24.1 | INR=3.4
22 days | 10 days | 437 | 145 | 28.4 | INR=9.0, creatinine 5.0 mg/dL
23 days | 11 days | Patient died of multiorgan failure
Normal Values | | <52 | <118 | <1.2

#### Comment

Several instances of acute liver failure have been reported in patients treated with erlotinib for non-small cell lung cancer. The onset was abrupt, within days of starting or restarting therapy. The liver disease was rapidly progressive with coagulopathy, hepatic encephalopathy, renal insufficiency and death from multiorgan failure within 1 to 2 weeks of presentation, despite prompt discontinuation of the erlotinib. Liver histology in this case demonstrated a severe acute hepatitis with submassive necrosis. The cause of the injury is unknown, but the rapidity of onset suggests immune factors. Cases of acute hepatitis and acute liver failure were not reported in the preregistration clinical trials of erlotinib that included several thousand patients. Thus, hepatic failure is rare and most likely to occur with rechallenge or if serum enzyme levels are not being monitored.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Erlotinib – Tarceva®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Erlotinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Erlotinib | 183321-74-6 | C22-H23-N3-O4 | Erlotinib Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 28 June 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published mentions that erlotinib has been linked to several cases of clinically apparent liver injury, 2 of which were fatal).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
Moore MJ, Goldstein D, Hamm J, Figer A, Hecht JR, Gallinger S, Au HJ, et al.; National Cancer Institute of Canada Clinical Trials Group. Erlotinib plus gemcitabine compared with gemcitabine alone in patients with advanced pancreatic cancer: a phase III trial of the National Cancer Institute of Canada Clinical Trials Group. J Clin Oncol 2007; 25: 1960-6. (Among 569 patients with advanced pancreatic cancer randomized to receive gemcitabine alone vs its combination with erlotinib, AST elevations above 5 times ULN occurred in 11% on the combination vs 8% on gemcitabine alone). 17452677
Shepherd FA, Rodrigues Pereira J, Ciuleanu T, Tan EH, Hirsh V, Thongprasert S, et al.; National Cancer Institute of Canada Clinical Trials Group. Erlotinib in previously treated non-small-cell lung cancer. N Engl J Med 2005; 353: 123-32. (Among 731 previously treated patients with non-small cell lung cancer treated with erlotinib or placebo, 5% stopped therapy because of side effects, but none because of hepatotoxicity; rates of ALT elevations not mentioned). 16014882
Ramanarayanan J, Scarpace SL. Acute drug induced hepatitis due to erlotinib. JOP 2007; 8: 39-43. (70 year old man with metastatic pancreatic cancer developed ALT elevations 2 weeks after starting erlotinib [ALT peak 580 U/L, Alk P 618 U/L], the ALT levels falling upon stopping therapy, but Alk P rising further). 17228132
Kulke MH, Blaszkowsky LS, Ryan DP, Clark JW, Meyerhardt JA, Zhu AX, Enzinger PC, et al. Capecitabine plus erlotinib in gemcitabine-refractory advanced pancreatic cancer. J Clin Oncol 2007; 25: 4787-92. (30 patients with refractory metastatic pancreatic cancer were treated with capecitabine and erlotinib; mild AST elevations occurred in 2 patients [7%]). 17947726
Liu W, Makrauer FL, Qamar AA, Jänne PA, Odze RD. Fulminant hepatic failure secondary to erlotinib. Clin Gastroenterol Hepatol 2007; 5: 917-20. (67 year old woman with non-small cell lung cancer developed mild ALT elevations and rash 4 weeks after starting erlotinib which resolved upon stopping, but 10 days after restarting she became jaundiced [bilirubin 13.6 mg/dL, ALT 2021 U/L, Alk P 304 U/L] and developed hepatic failure and died 11 days later: Case 2). 17625975
Thomas MB, Chadha R, Glover K, Wang X, Morris J, Brown T, Rashid A, et al. Phase 2 study of erlotinib in patients with unresectable hepatocellular carcinoma. Cancer 2007; 110: 1059-67. (40 patients with unresectable hepatocellular carcinoma were treated with 1 to 16 28-day courses of erlotinib; AST elevations occurred in 7 patients [18%], but were above 5 times ULN in only 1 [2.5%]). 17623837
Saif MW. Erlotinib-induced acute hepatitis in a patient with pancreatic cancer. Clin Adv Hematol Oncol 2008; 6: 191-9. (52 year old man with advanced pancreatic cancer developed rising levels of ALT and Alk P 7 weeks after starting erlotinib, with peak levels at week 10 [bilirubin 0.7 mg/dL, ALT 193 U/L, Alk P 376 U/L], which fell to baseline two months after stopping: Case 1). 18391918
Saif MW. Hepatic failure and hepatorenal syndrome secondary to erlotinib. Safety reminder. JOP 2008; 9: 748-52. (Review of the hepatotoxicity of erlotinib and its use in patients with preexisting liver dysfunction). 18981559
Ramanarayanan J, Krishnan GS. Review: hepatotoxicity and EGFR inhibition. Clin Adv Hematol Oncol 2008; 6: 200-1. (Review of hepatotoxicity of EGF receptor tyrosine kinase inhibitors focusing upon erlotinib and gefitinib). 18391919
Pellegrinotti M, Fimognari FL, Franco A, Repetto L, Pastorelli R. Erlotinib-induced hepatitis complicated by fatal lactic acidosis in an elderly man with lung cancer. Ann Pharmacother 2009; 43: 542-5. (77 year old man with non-small cell lung cancer developed shortness of breath and delirium 12 days after starting erlotinib [bilirubin 1.0 mg/dL, ALT 1299 U/L, LDH 5990 U/L, creatinine 4.4 mg/dL], with lactic acidosis [pH 7.1] and rapid demise within hours of presentation). 19261961
Huang YS, An SJ, Chen ZH, Wu YL. Three cases of severe hepatic impairment caused by erlotinib. Br J Clin Pharmacol 2009; 68: 464-7. (Three men, ages 31, 58 and 72 years, with non-small cell lung cancer developed hepatotoxicity after 2 to 7 days of erlotinib therapy [bilirubin 1.4, 6.7 and 0.9 mg/dL, ALT 896, 745 and 1412 U/L, Alk P not given], all dying of hepatic failure within 2-14 days of presentation). 19740406
Erlotinib: potentially fatal in cases of liver failure: a contraindication. Prescrire Int 2009; 18: 167. (Short discussion of report of 15 cases of liver failure in patients taking erlotinib, many had preexisting liver involvement due to cancer). 19746532
Schacher-Kaufmann S, Pless M. Acute Fatal Liver Toxicity under Erlotinib. Case Rep Oncol 2010; 3: 182-8. (53 year old with non-small cell lung cancer developed anorexia within 9 days, abdominal pain and fever after 17 days at which point erlotinib was stopped, but she then developed jaundice [bilirubin 4.7 mg/dL, ALT 884 U/L, Alk P 814 U/L] and progressive liver failure with thrombotic microangiopathy, dying 2 weeks after stopping erlotinib). 20740194
Steins M, Thomas M, Geissler M. Erlotinib. Recent Results Cancer Res 2010; 184: 21-31. (Review of development, mechanism of action, efficacy and safety of erlotinib in pancreatic, liver and non-small cell lung cancer; class specific adverse effects of EGFR inhibitors include xerosis, acneiform eruptions, eczema and diarrhea; rarely these agents cause interstitial lung disease and hepatotoxicity). 20072828
Ohashi Y, Suzuki K, Sakurai M, Ishikawa H, Onishi T, Nakagaki S, Kato T, et al. [Safety analysis of eight patients treated with erlotinib after severe gefitinib-induced liver injury]. Gan To Kagaku Ryoho 2010; 37: 1307-11. Japanese. (Abstract only: only one of 8 patients with severe gefitinib hepatotoxicity developed liver injury when switched to erlotinib, whereas the liver injury usually recurred upon restarting gefitinib, even at lower doses). 20647715
Takeda M, Okamoto I, Fukuoka M, Nakagawa K. Successful treatment with erlotinib after gefitinib-related severe hepatotoxicity. J Clin Oncol 2010; 28: e273-4. (66 year old woman with lung cancer developed ALT elevations after 36 weeks of treatment with gefitinib [ALT peak ~1011 U/L], resolving within 8 weeks of stopping and not recurring on starting erlotinib). 20385983
Kim ST, Lee J, Kim JH, Won YW, Sun JM, Yun J, Park YH, et al. Comparison of gefitinib versus erlotinib in patients with non-small cell lung cancer who failed previous chemotherapy. Cancer 2010; 116: 3025-33. (Retrospective analysis of 467 patients with non-small cell lung cancer treated with either gefitinib or erlotinib found similar rates of clinical response; no discussion of adverse events). 20564408
Ku GY, Chopra A, de Lima Lopes G Jr. Successful treatment of two lung cancer patients with erlotinib following gefitinib-induced hepatotoxicity. Lung Cancer 2010; 70: 223-5. (Two men, ages 52 and 88 years, with non-small cell lung cancer developed serum ALT elevations 4 and 6 weeks after starting gefitinib [bilirubin normal, peak ALT 354 and 297 U/L], resolving rapidly on stopping and not recurring when switched to erlotinib). 20817304
Gunturu KS, Abu-Khalaf M, Saif MW. Hepatic failure and hepatorenal syndrome secondary to erlotinib: a possible etiology of complications in a patient with pancreatic cancer. JOP 2010; 11: 484-5. (39 year old man with advanced pancreatic cancer developed weakness and rash after 3 days of erlotinib therapy [bilirubin 4.0 rising to 17.2 mg/dL, ALT 489 U/L], rapidly progressing to liver failure associated with diffuse liver metastases and malignant ascites). 20818124
Nakatomi K, Nakamura Y, Tetsuya I, Kohno S. Treatment with gefitinib after erlotinib-induced liver injury: a case report. J Med Case Reports 2011; 5: 593. (31 year old woman with metastatic lung cancer developed enyzme elevations 4 weeks after starting erlotinib [peak ALT 3130 U/L] that fell to normal within 3 weeks of stopping, and did not rise again when she was started on gefitinib). 22188652
Lai YC, Lin PC, Lai JI, Hsu SY, Kuo LC, Chang SC, Wang WS. Successful treatment of erlotinib-induced acute hepatitis and acute interstitial pneumonitis with high-dose corticosteroid: a case report and literature review. Int J Clin Pharmacol Ther 2011; 49: 461-6. (74 year old man developed interstitial pneumonitis and mild serum enzyme elevations 1 month after starting erlotinib [ALT 116 U/L], both of which improved within days on high dose corticosteroids). 21726497
Kijima T, Shimizu T, Nonen S, Furukawa M, Otani Y, Minami T, Takahashi R, et al. Safe and successful treatment with erlotinib after gefitinib-induced hepatotoxicity: difference in metabolism as a possible mechanism. J Clin Oncol 2011; 29: e588-90. (Two women, ages 67 and 83 years, with lung cancer developed elevated aminotransferase levels 4 and 8 weeks after starting gefitinib [peak ALT 731 and ~450 U/L, bilirubin and Alk P not given], which resolved upon stopping, recurred on restarting, but did not recur when erlotinib was used). 21502555
Kunimasa K, Yoshioka H, Iwasaku M, Nishiyama A, Korogi Y, Masuda G, Takaiwa T, et al. Successful treatment of non-small cell lung cancer with gefitinib after severe erlotinib-related hepatotoxicity. Intern Med 2012; 51: 431-4. (64 year old woman with non-small cell lung cancer developed abnormal liver tests 5 weeks after starting erlotinib [bilirubin normal, ALT 129, Alk P 819 U/L], which improved on stopping, but recurred on restarting, but did not recur upon switching to gefinitib). 22333382
Yang ZY, Yuan JQ, Di MY, Zheng DY, Chen JZ, Ding H, Wu XY, et al. Gemcitabine plus erlotinib for advanced pancreatic cancer: a systematic review with meta-analysis. PLoS One 2013; 8: e57528. (Review of literature on efficacy and safety of the combination of erlotinib and gemcitabine for advanced pancreatic cancer; the addition of erlotinib was associated with a prolongation of survival by 0.3 months and the adverse event rate was high "but not surprising"; no mention of hepatotoxicity). 23472089
Kitade H, Yamada T, Igarashi S, Hokkoku K, Mori M, Shintaku K, Sagawa M, et al. [Efficacy of low-dose erlotinib against gefitinib-induced hepatotoxicity in a patient with lung adenocarcinoma harboring EGFR mutations]. Gan To Kagaku Ryoho 2013; 40: 79-81. (80 year old woman developed ALT elevations [3 times ULN] on gefitinib, which resolved on stopping and did not recur on erlotinib [for 3 years]). 23306923
Takimoto T, Kijima T, Otani Y, Nonen S, Namba Y, Mori M, Yokota S, et al. Polymorphisms of CYP2D6 gene and gefitinib-induced hepatotoxicity. Clin Lung Cancer 2013; 14: 502-7. (Distribution of polymorphisms of CYP 2D6 gene were similar in 55 patients who developed ALT elevations during gefitinib therapy as found in the general Japanese population; 17 patients were switched to erlotinib and did not have recurrence of injury). 23664723
Yoshida T, Yamada K, Azuma K, Kawahara A, Abe H, Hattori S, Yamashita F, et al. Comparison of adverse events and efficacy between gefitinib and erlotinib in patients with non-small-cell lung cancer: a retrospective analysis. Med Oncol 2013; 30: 349. (Comparison of side effects in 107 patients with non-small cell lung cancer treated with gefitinib and 35 with erlotinib found "liver dysfunction" more frequent with gefitinib than erlotinib [13% vs 6%], whereas overall adverse events leading to drug discontinuation were less common [13% vs 26%]). 23263831
Yonesaka K, Suzumura T, Tsukuda H, Hasegawa Y, Ozaki T, Sugiura T, Fukuoka M. Erlotinib is a well-tolerated alternate treatment for non-small cell lung cancer in cases of gefitinib-induced hepatotoxicity. Anticancer Res 2014; 34: 5211-5. (Among 25 patients with advanced NSCLC treated with gefitinib, 7 developed ALT elevations above 5 times ULN, all of whom then tolerated erlotinib [for 1 month to several years] with no or only minor enzyme elevations). 25202117
Durand M, Logerot S, Fonrose X, Schir E. [Treatment with erlotinib after gefitinib induced hepatotoxicity: literature review and case report]. Therapie 2014; 69: 163-8. French. (Patient with NSCLC developed marked ALT elevations on gefinitib therapy with positive rechallenge, who nevertheless subsequently tolerated erlotinib without recurrence: Abstract only). 24926635
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 49 were attributed to antineoplastic agents [5.5%], 9 of which were attributed to kinase inhibitors [imatinib=5, lapatinib=2, regorafenib=1], but none to erlotinib). 25754159
Bui N, Wong-Sefidan I. Reactivation of hepatitis B virus after withdrawal of erlotinib. Curr Oncol 2015; 22: 430-2. (62 year old woman with metastatic adenocarcinoma of the lung developed severe diarrhea and dehydration 4 weeks after starting erlotinib, which was stopped and one week later she was found to have de novo serum enzyme elevations [ALT 267, Alk P 448 U/L, bilirubin not given], at which time HBsAg was detetctable without HBeAg in serum with HBV DNA level of 307 IU/mL; later tolerating restarting erlotinib while being treated for hepatitis B with entecavir). 26715877
Zenke Y, Umemura S, Sugiyama E, Kirita K, Matsumoto S, Yoh K, Niho S, et al. Successful treatment with afatinib after grade 3 hepatotoxicity induced by both gefitinib and erlotinib in EGFR mutation-positive non-small cell lung cancer. Lung Cancer 2016; 99: 1-3. (57 year old man with NSCLC developed ALT elevations 7 weeks after starting gefinitib [bilirubin 2.0 mg/dL, ALT peak 594 U/L], which resolved upon stopping but he then developed worsening jaundice within a week of starting erlotinib [bilirubin 5.4 mg/dL, ALT normal], and he later tolerated afatinib; genetic testing revealed Gilbert syndrome and "poor metabolizer" phenotype of CYP 3A5). 27565905
Ueda H, Hayashi H, Kudo K, Takeda M, Nakagawa K. Successful treatment with afatinib after gefitinib- and erlotinib-induced hepatotoxicity. Invest New Drugs 2016; 34: 797-9. (67 year old woman with metastatic NSCLC developed ALT elevations 16 weeks after starting gefitinib [ALT 223 U/L] which improved upon stopping, recurred with restarting gefitinib and later recurred 10 weeks after starting erlotinib [ALT 262 U/L), which improved on stopping but recurred even with lower doses, but subsequent ALT levels remained normal on switching to afatinib). 27550238
Toba H, Sakiyama S, Takizawa H, Tangoku A. Safe and successful treatment with afatinib in three postoperative non-small cell lung cancer patients with recurrences following gefitinib/erlotinib-induced hepatotoxicity. J Med Invest 2016; 63 (1-2): 149-51. (Two women and one man, ages 63 to 73 years with NSCLC developed ALT elevations 4-8 weeks after starting gefitinib [which recurred in one 6 weeks after switching to erlotinib], but all three tolerated long term afatinib [7 months] without recurrence of enzyme elevations). 27040072
Bunchorntavakul C, Reddy KR. Drug hepatotoxicity: newer agents. Clin Liver Dis 2017; 21: 115-34. (Review of the hepatotoxicity of recently approved medications including the tyrosine kinase inhibitors and erlotinib which has been linked to serum enzyme elevations above 5 times ULN in 10-14% of patients and to individual cases of severe hepatotoxicity, some of which have been fatal). 27842767

## OTHER REFERENCE LINKS

1. Recent References on Erlotinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Erlotinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Erlotinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Erlotinib)